# Aldesleukin

## OVERVIEW

### Introduction

Aldesleukin is a recombinant form of human interleukin-2, a cytokine that stimulates the proliferation and maturation of T cells, which is used in immune therapy of renal cell cancer and malignant melanoma. When given in high doses, interleukin-2 regularly causes mild-to-moderate elevations in serum enzymes and bilirubin, but it rarely results in clinically significant acute liver injury.

### Background

Aldesleukin (al" des loo' kin) is recombinant form of interleukin-2 (IL-2), a human cytokine produced by macrophages and lymphocytes that induces the proliferation and maturation of T cells. Also known as T cell growth factor, interleukin-2 is a critical cytokine in the adaptive immune process and interacts with specific T cell receptors to activate intracytoplasmic pathways that lead to proliferation and differentiation of immature T lymphoblasts into mature and reactive T cells that play an important role in immune responses to foreign proteins, viruses and bacteria and tumor cells. A recombinant form of interleukin-2 has been developed and shown to be an immune modulator and to have antitumor activity against several malignancies, but most convincingly renal cell cancer and malignant melanoma. Aldesleukin was approved for use in the United States for malignant melanoma in 1992 and indications were subsequently broadened and now include metastatic renal cell carcinoma and metastatic malignant melanoma. Aldesleukin is available as lyophilized powder in vials of 22 million IU under the brand name Proleukin. The typical dose is 600,000 IU/kg intravenously every 8 hours for a maximum of 14 doses, which can be repeated after a 9 day rest depending upon tolerance. Side effects are common, particularly with high dose interleukin-2 which should be administered in a hospital setting under the supervision of physicians experienced in the use of anticancer agents. Common side effects include fatigue, fever, chills, nausea, diarrhea, and capillary leak syndrome which can cause peripheral edema, hypotension, renal insufficiency and pulmonary edema. Less common, but potentially severe adverse reactions include shock, anaphylaxis, severe infections, autoimmune conditions and neurologic complications including somnolence, stupor and coma.

### Hepatotoxicity

In multiple phase 2 and 3 clinical trials, interleukin-2 was found to cause mild-to-moderate serum enzyme elevations in at least half of patients receiving intravenous therapy for malignancies. These elevations were generally transient and without obvious symptoms of liver injury, but rose to levels above 5 to 10 times ULN and necessitated early discontinuation or delay in further therapy in some patients. Extended courses of high dose interleukin-2 commonly lead to cholestasis, with increases in serum bilirubin and bile acids within 5 to 7 days of starting therapy followed by rises in alkaline phosphatase and aminotransferase levels. These changes reverse rapidly with discontinuation. The general pattern of bilirubin and enzyme elevations in these studies resembled the jaundice of sepsis or benign postoperative cholestasis and suggested a direct effect of IL-2 on bile and bile salt transport and secretion. With currently recommended doses given for 5 days these effects are less evident. In addition, instances of idiosyncratic clinically apparent acute liver injury with jaundice attributable to aldesleukin therapy have not been reported, although the product label mentions "hepatitis" as a potential complication of therapy. Thus, interleukin-2 has been clearly linked to serum enzyme elevations and cholestasis during treatment, but has not been implicated in cases of idiosyncratic, acute liver injury with jaundice.

Likelihood score: C[HD] (probable cause of clinically apparent liver injury when given in high doses).

### Mechanism of Injury

The mechanism by which interleukin-2 infusions might cause liver injury is unclear as it is a recombinant human protein and thus is unlikely to have direct hepatotoxicity. The induction of activated T cells, however, may be associated with some degree of hepatic inflammation and injury, but is not likely to cause frank acute liver damage. Furthermore, interleukin-2 also has multiple other actions that may account for its many side effects on endothelial cells, brain, kidney and hepatic function. Interleukin-2 has also been implicated in causing autoimmune conditions and vasculitis in other organs which may result in secondary effects on the liver.

### Outcome and Management

The serum enzyme and bilirubin elevations during aldesleukin therapy are generally self-limited and benign. In situations in which ALT or AST levels rise and remain above 5 times ULN, dose modification or temporary discontinuation of the intravenous infusions is prudent.

Other recombinant cytokines and polypeptides used medically include interferon alfa, interferon beta and interferon gamma as well as several hematopoietic growth factors such as erythropoietin, granulocyte-macrophage colony stimulating factor and interleukin-11 (oprelvekin).

Drug Class: Antineoplastic Agents, Cytokines, Biologic Response Modifiers

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aldesleukin – Proleukin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Aldesleukin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aldesleukin | 110942-02-4 | Cytokine | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 05 May 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of recombinant interleukin-2).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents does not discuss IL-2 or aldesleukin).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, Longo DL, Mitsiades C, Richardson P. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Fisher B, Keenan AM, Garra BS, Steinberg SM, White DE, DiBisceglie AM, Hoofnagle JH, et al. Interleukin-2 induces profound reversible cholestasis: a detailed analysis in treated cancer patients. J Clin Oncol 1989; 7: 1852-62. (Among 8 prospectively followed patients with malignancies receiving IL-2 [100,000 IU/kg 3 times daily for 5 days], serum bilirubin levels rose from 0.5 to 4.7 mg/dL [3.4 mg direct], becoming abnormal by day 3 and peaking on days 6-8 with a similar pattern of cholylglycine levels and mild rises in ALT, AST and Alk P becoming abnormal by day 6, all values returning to normal within one month). 2585024
Interleukin-2. Med Lett Drugs Ther 1990; 32 (826): 85-6. (Concise summary of the mechanism of action, clinical efficacy and safety of recombinant IL-2 before its approval, but in response to its availability on an experimental basis for use in renal cell cancer and malignant melanoma mentions side effects of increased capillary permeability with fluid retention, hypotension, renal insufficiency and pulmonary edema as well as severe malaise, fever, nausea, diarrhea, anemia and hyperbilirubinemia). 2202892
Fyfe G, Fisher RI, Rosenberg SA, Sznol M, Parkinson DR, Louie AC. Results of treatment of 255 patients with metastatic renal cell carcinoma who received high-dose recombinant interleukin-2 therapy. J Clin Oncol 1995; 13: 688-96. (Among 255 patients with metastatic renal cell cancer treated with aldesleukin in 7 clinical trials, the overall response rate was 14% and side effects were common [4% died], but most were rapidly reversible including capillary leak syndrome and hypotension; elevations in ALT occurred in 72%, alkaline phosphatase in 72%, and bilirubin in 85%; 11% of patients had "grade 4" increases in bilirubin and ALT, but all resolved with stopping IL-2 infusions without chronicity or mortality). 7884429
Noble S, Goa KL. Aldesleukin (recombinant interleukin-2). BioDrugs 1997; 7: 394-422. (Review of the mechanism of action, pharmacology, efficacy and safety of IL-2 as therapy of malignant melanoma mentions hepatic side effects of increase serum enzymes and bilirubin, intrahepatic cholestasis and jaundice). 18031103
Negrier S, Escudier B, Lasset C, Douillard JY, Savary J, Chevreau C, Ravaud A, et al. Recombinant human interleukin-2, recombinant human interferon alfa-2a, or both in metastatic renal-cell carcinoma. Groupe Français d'Immunothérapie. N Engl J Med 1998; 338: 1272-8. (Among 425 patients with metastatic renal cell cancer treated with IL-2 or interferon alfa or both, response rates as well as adverse events rates were higher with the combination; ALT or AST elevations above 5 times ULN occurring in 11% with IL-2 alone, 3% with interferon and 11% with the combination, but "all patients recovered and returned to their pretreatment status"). 9562581
Atkins MB, Lotze MT, Dutcher JP, Fisher RI, Weiss G, Margolin K, Abrams J, et al. High-dose recombinant interleukin 2 therapy for patients with metastatic melanoma: analysis of 270 patients treated between 1985 and 1993. J Clin Oncol 1999; 17: 2105-16. (Among 270 patients with metastatic melanoma treated with high dose intravenous IL-2 [every 8 hours for 5 days repeated as tolerated], the response rate was 16% and acute toxicity was common with elevations of ALT in 39% [above 5 times ULN in 7%], bilirubin in 51% and Alk P in 13%). 10561265
Schlegel PJ, Samlowski WE, Ward JH. Autoimmune hemolytic anemia in a patient with chronic lymphocytic leukemia and renal cell carcinoma after treatment with high-dose intravenous bolus interleukin-2. J Immunother 2000; 23: 507-8. (66 year old man with renal cell cancer and CLL developed Coombs positive hemolytic anemia after a 5 day course of intravenous IL-2 which resolved with prednisone therapy). 10916762
Chi KH, Myers JN, Chow KC, Chan WK, Tsang YW, Chao Y, Yen SH, Lotze MT. Phase II trial of systemic recombinant interleukin-2 in the treatment of refractory nasopharyngeal carcinoma. Oncology 2001; 60: 110-5. (Among 14 patients with nasopharyngeal cancer who received 1 to 4 cycles of IL-2, no objective responses were seen and side effects were frequent including ALT or AST elevations in all 14 patients). 11244324
Abraham D, McGrath KG. Hypersensitivity to aldesleukin (interleukin-2 and proleukin) presenting as facial angioedema and erythema. Allergy Asthma Proc 2003; 24: 291-4. (61 year old woman developed facial erythema and swelling within a day of starting IL-2 which persisted during the 5 days of therapy, resolved after stopping and recurred with further courses; accompanied by specific anti-aldesleukin IgE; liver tests were reported to be normal). 12974198
Yang JC, Sherry RM, Steinberg SM, Topalian SL, Schwartzentruber DJ, Hwu P, Seipp CA, et al. Randomized study of high-dose and low-dose interleukin-2 in patients with metastatic renal cancer. J Clin Oncol 2003; 21: 3127-32. (Among 306 patients with metastatic renal cell cancer treated with high or low doses of IL-2 [72,000 or 720,000 IU/kg], responses were similar in frequency but more sustained with high doses that also had higher levels of toxicity; ALT or AST elevations above 5 times ULN occurring in 0.7% vs 3.2%). 12915604
Hauschild A, Weichenthal M, Balda BR, Becker JC, Wolff HH, Tilgen W, Schulte KW, et al. Prospective randomized trial of interferon alfa-2b and interleukin-2 as adjuvant treatment for resected intermediate- and high-risk primary melanoma without clinically detectable node metastasis. J Clin Oncol 2003; 21: 2883-8. (Among 255 patients with malignant melanoma given cycles of low dose interferon alfa and IL-2 or no treatment for 48 weeks, the combination therapy failed to show any effect, and while adverse events were common, they were generally self-limited; 9 patients required early discontinuation, one because of liver test abnormalities but details not given). 12885805
McDermott DF, Regan MM, Clark JI, Flaherty LE, Weiss GR, Logan TF, Kirkwood JM, et al. Randomized phase III trial of high-dose interleukin-2 versus subcutaneous interleukin-2 and interferon in patients with metastatic renal cell carcinoma. J Clin Oncol 2005; 23: 133-41. (Among 192 patients with metastatic renal cell carcinoma treated with high or standard doses of IL-2 and interferon, response rates were higher with higher doses [23% vs 10%] as were "hepatic toxicities" [12% vs 2%], and one patient on high doses died of capillary leak syndrome one week later). 15625368
Banerji A, Weller PF, Sheikh J. Cytokine-associated angioedema syndromes including episodic angioedema with eosinophilia (Gleich's Syndrome). Immunol Allergy Clin North Am 2006; 26: 769-81. (Review of angioedema syndromes occurring with cytokine therapies including summary of a case report [Abraham 2003]). 17085290
Klapper JA, Downey SG, Smith FO, Yang JC, Hughes MS, Kammula US, Sherry RM, et al. High-dose interleukin-2 for the treatment of metastatic renal cell carcinoma: a retrospective analysis of response and survival in patients treated in the surgery branch at the National Cancer Institute between 1986 and 2006. Cancer 2008; 113: 293-301. (Review of 20 years of experience with treating 259 patients with metastatic renal cell cancer at the Surgery Branch, NIH mentions that responses occurred in 53 patients [20%] and AST elevations in 74 [29%] but were above 5 times ULN in only 5 [2%], while elevated bilirubin levels occurred in 155 [60%] but were "readily reversible" with stopping). 18457330
McDermott DF. The application of high-dose interleukin-2 for metastatic renal cell carcinoma. Med Oncol 2009; 26 Suppl 1: 13-7. (Review of the use of high dose IL-2 for metastatic renal cell cancer 17 years after its approval mentions objective response rates of 15% and complete responses of 7% that can result in long term survival; no discussion of toxicity). 19148594
INSIGHT-ESPRIT Study Group; SILCAAT Scientific Committee. Interleukin-2 therapy in patients with HIV infection. N Engl J Med 2009; 361: 1548-59. (Among 5806 patients with HIV infection on antiretroviral therapy in two controlled trials, the addition of IL-2 had no effect on rates of opportunistic infections or death; no discussion of acute toxicities). 19828532
Schwartzentruber DJ, Lawson DH, Richards JM, Conry RM, Miller DM, Treisman J, Gailani F, et al. gp100 peptide vaccine and interleukin-2 in patients with advanced melanoma. N Engl J Med 2011; 364: 2119-27. (Among 185 patients with advanced melanoma treated with IL-2 with or without an experimental melanoma peptide vaccine, response rates were higher in the vaccine group [16% vs 6%] while toxicities were mostly similar, "hepatic" toxic effects occurring in 39% vs 40%). 21631324
Markowitz N, Lopardo G, Wentworth D, Gey D, Babiker A, Fox L, Tavel J; STALWART Study Group. Long-term effects of intermittent IL-2 in HIV infection: extended follow-up of the INSIGHT STALWART Study. PLoS One 2012; 7: e47506. (Long term follow up of HIV infected patients who were treated with IL-2 reported that the acute adverse events did not persist upon aldesleukin discontinuation). 23082173
Baldo BA. Side effects of cytokines approved for therapy. Drug Saf 2014; 37: 921-43. (Review of the safety and tolerance of therapeutic cytokines including aldesleukin [recombinant IL2]; mentions many of its severe side effects including cardiovascular, hemodynamic, pulmonary, gastrointestinal, endocrine, renal, infectious and dermatologic, but not liver toxicity or elevations in bilirubin or ALT levels). 5270293
McDermott DF, Cheng SC, Signoretti S, Margolin KA, Clark JI, Sosman JA, Dutcher JP, et al. The high-dose aldesleukin "select" trial: a trial to prospectively validate predictive models of response to treatment in patients with metastatic renal cell carcinoma. Clin Cancer Res 2015; 21: 561-8. (Among 128 patients with metastatic renal cell cancer treated with IL-2, previously suggested predictive biomarkers for favorable outcome did not help with selection criteria for treatment; no discussion of adverse events). 25424850
Clark JI, Wong MKK, Kaufman HL, Daniels GA, Morse MA, McDermott DF, Agarwala SS, et al. Impact of sequencing targeted therapies with high-dose interleukin-2 immunotherapy. Clin Genitourin Cancer 2017; 15: 31-41. (Review of a large observational study of metastatic renal cell carcinoma including 352 patients who received high dose aldesleukin therapy mentions 5 treatment related deaths, but none were due to liver disease). 27916626

## OTHER REFERENCE LINKS

1. Recent References on Aldesleukin: Interleukin-2: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Aldesleukin+Interleukin-2/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Aldesleukin: Interleukin-2: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Aldesleukin+Interleukin-2)